# Saquinavir

## OVERVIEW

### Introduction

Saquinavir is an antiretroviral protease inhibitor that is used in the therapy and prevention of human immunodeficiency virus (HIV) infection and the acquired immunodeficiency syndrome (AIDS). Saquinavir can cause transient and usually asymptomatic elevations in serum aminotransferase levels and, rarely, can lead to clinically apparent acute liver injury. In HBV or HCV coinfected patients, highly active antiretroviral therapy with saquinavir may result of an exacerbation of the underlying chronic hepatitis B or C.

### Background

Saquinavir (sa kwin' a vir) is an antiretroviral protease inhibitor that acts by binding to the catalytic site of the HIV protease, thereby preventing the cleavage of viral polyprotein precursors into mature, functional proteins that are necessary for viral replication. Saquinavir was approved for use in the United States in 1995 and is still widely used in combination with other antiretroviral agents for the prevention and treatment of HIV infection in adults and children. Saquinavir is available under the brand name Invirase in 200 mg capsules and 500 mg tablets. It is usually used in combination with a low dose of ritonavir, which improves its pharmacokinetics and allows for twice daily dosing. The recommended dose of saquinavir is 1000 mg in combination with 100 mg of ritonavir, both taken twice daily. The most common side effects of HIV protease inhibitors include gastrointestinal upset, diarrhea, nausea, fatigue and, with long term use, hyperlipidemia and lipodystrophy.

### Hepatotoxicity

Some degree of serum aminotransferase elevations occur in a high proportion of patients taking saquinavir containing antiretroviral regimens. Moderate-to severe elevations in serum aminotransferase levels (>5 times the upper limit of normal) are found in 3% to 10% of patients, although rates may be higher in patients with HIV-HCV coinfection. These elevations are usually asymptomatic and self-limited and can resolve even with continuation of the medication.

Clinically apparent liver injury from saquinavir is rare, and the clinical pattern of liver injury, latency and recovery have not been well defined. However, several other HIV protease inhibitors have been associated with symptomatic acute liver injury for which the clinical pattern has been defined. The injury usually arises 1 to 8 weeks after onset and has variable patterns of liver enzyme elevation, from hepatocellular to cholestatic. Immunoallergic features (rash, fever, eosinophilia) are uncommon, as is autoantibody formation. The injury is usually self-limited and resolves rapidly upon stopping the implicated protease inhibitor (Case 1).

Saquinavir has also been associated with a rapid onset (1 to 4 days) acute hepatic injury in patients who are taking rifampin and perhaps other agents that affect hepatic CYP 450 activity, such as phenobarbital (Case 1). This syndrome has the appearance of direct hepatotoxicity with acute hepatic necrosis. Jaundice is rare and the injury resolves rapidly once saquinavir is stopped. The cause of this rapid onset syndrome is unknown, but is probably caused by drug-drug interactions.

Finally, initiation of saquinavir based highly active antiretroviral therapy can lead to exacerbation of an underlying chronic hepatitis B or C in coinfected individuals, typically arising 2 to 12 months after starting therapy and associated with a hepatocellular pattern of serum enzyme elevations and concurrent increases in serum levels of hepatitis B virus (HBV) DNA or hepatitis C virus (HCV) RNA. These exacerbations of chronic viral hepatitis may represent immune reconstitution syndrome and can occur with initiation of any potent antiretroviral regimen. Saquinavir therapy has not been clearly linked to lactic acidosis and acute fatty liver that is reported in association with several nucleoside analogue reverse transcriptase inhibitors.

Likelihood score: D (Possible rare cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of liver enzyme elevations during saquinavir therapy is not known. Saquinavir is extensively metabolized by the liver via the cytochrome P450 system (CYP 3A4), and production of a toxic intermediate may underlie liver injury. Drugs that interact with the P450 system may predispose to hepatic injury from saquinavir. In patients with HCV or HBV coinfection, initiation of highly active antiretroviral therapy may be associated with flares of the underlying chronic hepatitis, which may be the result of reconstitution of the immune system, viral interactions or direct effects of the agents on the hepatitis virus.

### Outcome and Management

The rare cases of clinically apparent liver injury attributed to saquinavir have been self-limited, and chronic hepatitis and vanishing bile duct syndrome have yet to be linked to saquinavir use. Rechallenge can lead to recurrence of liver injury and should be avoided. There is little evidence of cross reactivity among the various protease inhibitors which are typically proteinomimetic and structurally unrelated. In general, these other agents can be safely substituted. The exacerbation of hepatitis B or C that can occur with saquinavir based antiretroviral therapies can be severe and lead to acute liver failure or progressive, end stage liver disease. Patients with HCV or HBV coinfection should be monitored prospectively for viral and serum aminotransferase levels and appropriate therapy instituted if possible.

References to saquinavir are included with references to all the HIV protease inhibitors in the overview section of Protease Inhibitors (Updated September 2017). Most of the HIV protease inhibitors in clinical use are proteinomimetic drugs and are structurally unrelated.

Drug Class: Antiviral Agents, Antiretroviral Agents

Other Drugs in the Subclass, Protease Inhibitors: Amprenavir, Atazanavir, Darunavir, Fosamprenavir, Indinavir, Lopinavir, Nelfinavir, Ritonavir, Tipranavir

## CASE REPORT

### Case 1. Acute anicteric but symptomatic hepatic injury due to saquinavir.

[Modified from: Vandercam B, Moreau M, Horsmans C, Gala JL. Acute hepatitis in a patient treated with saquinavir and ritonavir: absence of cross-toxicity with indinavir. Infection 1998; 26:313. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/9795794)]

A 46 year old man with HIV infection and idiopathic epilepsy developed nausea and vomiting a few hours after the first doses of an antiretroviral regimen of stavudine (40 mg), saquinavir (400 mg) and ritonavir (300 mg). He stopped the three medications and recovered rapidly. One week later, he restarted the medications and again developed nausea and vomiting within a few hours. He had no previous history of liver disease or exposure to viral hepatitis. He had been taking valproate, phenobarbital and primidone for epilepsy for many years and was on acyclovir as prophylaxis against herpes simplex for several months. Physical examination was normal and laboratory tests the day after the second single dose exposure showed ALT 1833 U/L, GGT 175 U/L without hyperbilirubinemia or eosinophilia. Tests for hepatitis A, B and C and other common viral infections that can affect the liver were negative. Serum levels of phenobarbital, valproate and primidone were in the normal range. The antiretroviral medications were stopped, symptoms resolved promptly, and serum enzyme abnormalities fell to normal within a few weeks. He was later restarted on stavudine in combination with lamivudine and indinavir without recurrence of symptoms or liver test abnormalities.

#### Key Points

Medication: | Saquinavir
Pattern: | Hepatocellular (R value=14.7 [using GGT instead of Alk P])
Severity: | Mild (serum aminotransferase elevations without jaundice)
Latency: | 1 day upon reexposure
Recovery: | 2 weeks
Other medications: | Valproate, phenobarbital, primidone, acyclovir, ritonavir, stavudine

#### Comment

While this case was considered “acute hepatitis”, it actually represented gastrointestinal intolerance and marked serum aminotransferase elevations in response to a single dose of saquinavir (with ritonavir). Both the onset and the recovery from the hepatic injury were rapid and the patient remained anicteric. The coadministration of phenobarbital, valproate and/or primidone may have played a role in the hepatic injury, all being metabolized by the P450 system and causing major drug-drug interactions. In addition, one cannot say for sure whether it was saquinavir or ritonavir that was responsible for the reaction. Interesting, a similar pattern of abrupt ALT elevations and symptoms has been described in patients receiving saquinavir and ritonavir in combination with rifampin, another well-known CYP 3A4 inducer.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Saquinavir – Invirase®

DRUG CLASS

Antiviral Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Saquinavir)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Saquinavir | 127779-20-8 | C38-H50-N6-O5 | Saquinavir Chemical Structure

## OTHER REFERENCE LINKS

1. Recent References on Saquinavir: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Saquinavir/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Saquinavir: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Saquinavir)